# Bicalutamide

## OVERVIEW

### Introduction

Bicalutamide is a second generation, oral nonsteroidal antiandrogen similar in structure to flutamide that has been used widely in the therapy of prostate cancer. Bicalutamide is associated with a low rate of serum enzyme elevations during therapy and has been linked to rare instances of liver injury.

### Background

Bicalutamide (bye" ka loo' ta mide) is an orally available nonsteroidal antiandrogen that is similar in structure to flutamide and nilutamide used in the treatment of prostate cancer. Bicalutamide acts by binding to intracellular androgen receptors and competitively inhibiting the action of endogenous androgens on sensitive tissue, including testes, prostate, breast, skin and hypothalamus. Bicalutamide was approved for use in the United States in 1995. Current indications are for the therapy of metastatic prostate cancer in combination with luteinizing hormone releasing hormone (LHRH) analogs such as leuprolide or goserelin. Bicalutamide is available in tablets of 50 mg generically and under the trade name of Casodex. The recommended dose is 50 mg once daily. Common side effects of bicalutamide include fatigue, drowsiness, anxiety, gynecomastia and loss of libido. Rare but potentially severe adverse events include acute liver injury, Stevens Johnson syndrome, and severe hemorrhage when used with warfarin for anticoagulation.

### Hepatotoxicity

Bicalutamide therapy is associated with mild, asymptomatic and transient elevations in serum aminotransferase levels in approximately 6% of patients. The frequency and height of the ALT elevations appears to be less with bicalutamide than flutamide. Similarly, there have been rare case reports of clinically apparent liver injury due to bicalutamide, but less frequently than with flutamide. In the Spanish pharmacovigilance study, there were 11 reports of hepatotoxicity from bicalutamide, none of which were fatal. On the other hand, the product label for bicalutamide mentions that a few cases of fatal hepatic failure have been reported. The clinical pattern of liver injury with bicalutamide appears to resemble that of flutamide. The latency to onset is usually 2 to 3 months, but can be shorter with reexposure and occasionally arises 4 to 6 months after starting. The typical pattern of serum enzyme elevations is hepatocellular and severe, fulminant cases have been described. Rash, fever and eosinophilia are not common and autoantibody formation is not described.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of bicalutamide hepatotoxicity is unknown. It is metabolized by the liver via the cytochrome P450 system, largely via CYP 3A4 which it can inhibit and thus cause drug-drug interactions. Thus, liver injury from bicalutamide may be caused by toxic or immunogenic metabolites of the agent. The lower frequency of hepatotoxicity from bicalutamide compared to flutamide may be due to its lower dose or its lower rate of hepatic metabolism.

### Outcome and Management

The mild ALT elevations during bicalutamide therapy are usually self-limiting even with continuation of the medication. The rare instances of clinically apparent liver injury have ranged in severity from mild self-limiting cases to fatal acute liver failure. Monitoring of liver tests during therapy is recommended. There is no information on cross sensitivity to hepatic injury among the various antiandrogens. Rechallenge should be avoided and switching therapy to flutamide or nilutamide cannot be recommended.

Drug Class: Antineoplastic Agents, Antiandrogens

## CASE REPORTS

### Case 1. Acute liver failure arising after two doses of bicalutamide.(1)

A 60 year old man with prostate cancer developed acute liver failure following two doses of bicalutamide and a few days after stopping a 3 month course of flutamide. Liver test results were reported to be normal at the time of diagnosis of prostate cancer. Following an initial month of therapy with cyproterone acetate, flutamide and monthly subcutaneous goserelin acetate was started. Although flutamide was well tolerated, it was discontinued after 3 months and bicalutamide was substituted. After the second dose of bicalutamide, the patient developed jaundice and confusion. All medications were stopped and he was admitted for evaluation and therapy. He had no previous history of liver disease, no risk factors for viral hepatitis and no recent use of alcohol or acetaminophen. Serum bilirubin was 19.5 mg/dL, and serum ALT was markedly elevated with minimal increase in alkaline phosphatase levels (Table). The INR was 2.2. Tests for hepatitis A, B, C and for EBV infection were negative as were autoantibodies. An abdominal ultrasound revealed no evidence of biliary disease or liver metastasis. The patient developed mental obtundation and required intensive care support, vitamin K, and lactulose. After an initial period of worsening, he improved slowly. Eight weeks later, serum enzymes and bilirubin levels were normal.

#### Key Points

Medication: | Bicalutamide, 50 mg, 2 doses, and flutamide, 750 mg daily for 3 months
Pattern: | Hepatocellular
Severity: | 4+ (jaundice, hospitalization, coagulopathy and encephalopathy)
Latency: | 2 days for bicalutamide, 3 months for flutamide
Recovery: | 2 months
Other medications: | Flutamide, cyproterone acetate, goserelin acetate

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Bicalutamide 50 mg daily for two days
2 | 0 | 2690 | 181 | 19.5 | INR=2.2
8 weeks | 8 weeks | Normal | Normal | Normal | Asymptomatic
Normal Values | | <35 | <130 | <1.2

#### Comment

Although widely cited as an example of bicalutamide hepatotoxicity, this case can only be said to be “possibly” related to bicalutamide and is much more likely due to flutamide hepatotoxicity with the typical abrupt hepatocellular pattern of injury arising after 3 months of therapy. Indeed, even with the most severe hepatic injury (in the absence of hemolysis), it would take more than 2 days for serum bilirubin to rise from normal to 19 mg/dL. Cyproterone has also be linked to similar cases of hepatocellular injury, but the appearance of jaundice several months after stopping this agent, makes it unlikely as the cause.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bicalutamide – Generic, Casodex®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=bicalutamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Bicalutamide | 90357-06-5 | C18-H14-F4-N2-O4-S

## CITED REFERENCE

1 Dawson LA, Chow E, Morton G. (1997). Fulminant hepatic failure associated with bicalutamide. Urology.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2023

Abbreviations: LHRH, luteinizing hormone releasing hormone; PSA, prostate specific-antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 699. (Expert review of hepatotoxicity published in 1999, mentions that flutamide has led to instances of severe hepatic necrosis and fulminant hepatic failure).
DeLeve LD. Flutamide. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 559. (Textbook on drug induced liver injury mentions that flutamide has been implicated in 46 cases of severe liver injury with 20 fatalities; bicalutamide is not discussed).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics; discusses the role of androgen receptor blockers in prostate cancer including bicalutamide, flutamide and nilutamide).
Kennealey GT, Furr BJ. (1991). Use of the nonsteroidal anti-androgen Casodex in advanced prostatic carcinoma. Urol Clin North Am. (Review of pharmacokinetics and early phase studies of bicalutamide for prostate cancer; no mention of hepatotoxicity).
Schellhammer P, Sharifi R, Block N, Soloway M, Venner P, Patternson AL, Sarosdy M, et al. (1995). A controlled trial of bicalutamide versus flutamide, each in combination with luteinizing hormone-releasing hormone analogue therapy, in patients with advanced prostate cancer. Casodex Combination Study Group. Urology. (Analysis of trial of bicalutamide vs flutamide in 813 men with prostate cancer at 60 sites; abnormal liver function reported in ~12% of flutamide vs ~8% of bicalutamide treated patients, but few details given as to nature, severity or reversibility).
Kotake T, Usami M, Isaka S, Shimazaki J, Oishi K, Yoshida O, Ozono S, et al. (1996). Hinyokika Kiyo. (Trial of escalating doses of bicalutamide for 12 weeks in 16 patients; 3 developed abnormal liver tests, but all reversed with stopping therapy [abstract only]).
Dawson LA, Chow E, Morton G. (1997). Fulminant hepatic failure associated with bicalutamide. Urology. (60 year old man with prostate cancer was given cyproterone and flutamide for 3 months and then switched to bicalutamide developing jaundice after 2 doses [bilirubin 19.5 mg/dL, ALT 2690 U/L, Alk P 181 U/L, INR 2.2 and encephalopathy], improving within 2 months: Case 1).
Chodak GW. (1997). Bicalutamide-associated fulminant hepatic failure. Urology. (Letter disputing the role of bicalutamide in case described by Dawson [1997] because flutamide had been stopped a few days before and was the more likely culprit).
Schellhammer PF. (1997). Fulminant hepatic failure associated with bicalutamide. Urology. (Letter regarding case report by Dawson [1997] expressing doubt that the injury was due to bicalutamide [given for 2 days only] rather than flutamide [given for 3 months] or cyproterone [given for 1 month]).
McLeod DG. (1997). Tolerability of nonsteroidal antiandrogens in the treatment of advanced prostate cancer. Oncologist. (Overview of the safety and side effects of the nonsteroidal antiandrogens; ALT elevations in 6% receiving bicalutamide vs 10% with flutamide; clinically apparent hepatitis can occur but is rare).
Palmberg C, Kylmala T, Tammela T. (1997). Reduction of flutamide-induced alanine aminotransferase elevation after replacement by bicalutamide in a patient with N+ disease treated with maximal androgen blockade as a primary treatment. Br J Urol. (46 year old man with prostate cancer developed ALT elevations [106 U/L] without jaundice after 21 months of flutamide [750 mg/day], which improved on stopping [to 73 U/L] and increased again [108 U/L] with restarting [500 mg/day]. Switching to bicalutamide [50 mg/day] was followed by decrease of ALT but not to normal [53 U/L]).
Tyrrell CJ, Kaisary AV, Iversen P, Anderson JB, Baert L, Tammela T, Chamberlain M, et al. (1998). A randomised comparison of 'Casodex' (bicalutamide) 150 mg monotherapy versus castration in the treatment of metastatic and locally advanced prostate cancer. Eur Urol. (European trial of bicalutamide vs orchiectomy in 1453 men with prostate cancer, found bicalutamide monotherapy less effective; no mention of serious adverse events or hepatotoxicity).
Schellhammer PF, Davis JW. (2004). An evaluation of bicalutamide in the treatment of prostate cancer. Clin Prostate Cancer. (Review of randomized trials of bicalutamide for prostate cancer with no new information on hepatotoxicity).
Thole Z, Manso G, Salgueiro E, Revuelta P, Hidalgo A. (2004). Hepatotoxicity induced by antiandrogens: a review of the literature. Urol Int. (Systematic review of the literature from the Spanish pharmacovigilance group; 21 reports on hepatotoxicity of cyproterone, 46 flutamide, 4 nilutamide and only 1 bicalutamide; 6 cases of hepatocellular carcinoma linked to cyproterone therapy).
Manso G, Thole Z, Salgueiro E, Revuelta P, Hidalgo A. (2006). Spontaneous reporting of hepatotoxicity associated with antiandrogens: data from the Spanish pharmacovigilance system. Pharmacoepidemiol Drug Saf. (Analysis of spontaneous reporting to Spanish Pharmacovigilance system found 88 cases of flutamide, 11 bicalutamide and 15 cyproterone hepatotoxicity, latency 3-6 months; 2 fatalities, both from flutamide).
Castro Beza I, Sánchez Ruiz J, Peracaula Espino FJ, Villanego Beltrán MI. (2008). Drug-related hepatotoxicity and hepatic failure following combined androgen blockade. Clin Transl Oncol. (61 year old man with prostate cancer developed jaundice 3 months after starting bicalutamide [bilirubin 11.5 mg/dL, ALT 1923 U/L, Alk P 169 U/L], and subsequently developed progressive liver failure and died).
O'Bryant CL, Flaig TW, Utz KJ. (2008). Bicalutamide-associated fulminant hepatotoxicity. Pharmacotherapy. (59 year old man with prostate cancer developed abdominal pain 4 days after restarting bicalutamide [bilirubin not given, ALT 111 rising to 2050 U/L, INR 3.4], which was followed by multiorgan failure and death in 4 days).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiandrogen).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiandrogen therapies).
Hussain S, Haidar A, Bloom RE, Zayouna N, Piper MH, Jafri SM. (2014). Bicalutamide-induced hepatotoxicity: A rare adverse effect. Am J Case Rep. (81 year old man with prostate cancer developed jaundice 3 weeks after starting bicalutamide [bilirubin 3.7 mg/dL, ALT 576 U/L, Alk P 223 U/L, INR 1.5], which improved rapidly after stopping).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 1 case [0.1%] was attributed to bicalutamide: 50 year old man with prostate cancer developed jaundice 4 months after starting bicalutamide [bilirubin 3.4 mg/dL, ALT 2412 U/L, Alk P 147 U/L, INR 1.2] with slow but complete resolution upon stopping).
Yun GY, Kim SH, Kim SW, Joo JS, Kim JS, Lee ES, Lee BS, et al. (2016). Atypical onset of bicalutamide-induced liver injury. World J Gastroenterol. (62 year old man with prostate cancer developed jaundice 19 weeks after starting bicalutamide [bilirubin 1.6 mg/dL, ALT 677 U/L, Alk P 87 U/L, INR 1.17], resolving completely within 3 months of stopping).
Crawford ED, Schellhammer PF, McLeod DG, Moul JW, Higano CS, Shore N, Denis L, et al. (2018). Androgen receptor targeted treatments of prostate cancer: 35 years of progress with antiandrogens. J Urol. (Review of the development of antiandrogen therapies of prostate cancer starting with discovery of the androgen sensitive nature of prostate cancer, the effects of orchiectomy, followed by the development of androgen receptor antagonists, first generation agents flutamide and nilutamide, second generation agent bicalutamide and third generation agents enzalutamide, apalutamide and darolutamide that have more potent androgen receptor inhibition).
Liu J, Agyapong G, Misra D, Taylor CD, Hirsh DA. (2019). A rare case of idiopathic cholestasis: Clinical conundrums complicating enzalutamide therapy in metastatic prostate cancer. Clin Case Rep. (88 year old man with metastatic prostate cancer developed jaundice one week after stopping a 5 month course of bicalutamide and starting enzalutamide while continuing on leuprolide [bilirubin 3.8 mg/dL, ALT 45 U/L, Alk P 654 U/L, GGT 988 U/L, INR 1.2], with little improvement after stopping all therapy and death from suspected progressive disease 2 weeks later).
Saito S. (2019). Successful recovery from multiple organ failure associated with bicalutamide and leuprorelin acetate for prostate cancer. Urol Case Rep. (79 year old man with metastatic prostate cancer developed renal failure, proteinuria, hypertension, pulmonary dysfunction and liver test abnormalities shortly after starting bicalutamide and leuprorelin [ALT 147 U/L, AST 89 U/L, creatinine 5.6 mg/dL, bilirubin and Alk P not provided], resolving with supportive care).
Vaishampayan UN, Heilbrun LK, Monk P, Tejwani S, Sonpavde G, Hwang C, Smith D, et al. (2021). Clinical efficacy of enzalutamide vs bicalutamide combined with androgen deprivation therapy in men with metastatic hormone-sensitive prostate cancer: a randomized clinical trial. JAMA Netw Open. (Among 71 men with advanced prostate cancer treated with either enzalutamide [160 mg] or bicalutamide [50 mg] daily with androgen-depletion therapy using a LHRH analog, the biochemical and overall survival outcomes were greater with enzalutamide than bicalutamide, particularly in Black subjects; no mention of hepatic adverse events).
Yanagisawa T, Kimura T, Mori K, Suzuki H, Sano T, Otsuka T, Iwamoto Y, et al. (2022). Abiraterone acetate versus nonsteroidal antiandrogen with androgen deprivation therapy for high-risk metastatic hormone-sensitive prostate cancer. Prostate. (Among 312 men with prostate cancer treated with abiraterone [1000 mg] or bicalutamide [80 mg] daily, overall and cancer specific survival were similar in the two groups, but adverse events were more common with abiraterone [27% vs 21%] as was “impaired liver function” [16% vs 2%], and there were no deaths or severe adverse events attributed to liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Bicalutamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=bicalutamide+AND+nitriles/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222006/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Bicalutamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=bicalutamide)